# Tinidazole

## OVERVIEW

### Introduction

Tinidazole is an orally available, broad spectrum antimicrobial agent used in the treatment of bacterial, protozoal and parasitic infections. Tinidazole is a nitroimidazole similar to metronidazole and is likely to have a similar spectrum and frequency of side effects, including a low rate of serum enzyme elevations during therapy and rare instances of clinically apparent acute liver injury.

### Background

Tinidazole (tye nid' a zole) is an oral, broad spectrum antimicrobial that has activity against bacteria as well as several parasites such as Entamoeba histolytica, Giardia duodenalis and Trichomonas vaginalis. Tinidazole is a nitroimidazole similar to metronidazole and is activated intracellularly by bacterial or parasitic enzymes to a radical anion, which damages large protein molecules and DNA. Tinidazole was approved for use in the United States in 2004 and current indications are for treatment of trichomoniasis, giardiasis, amebiasis and bacterial vaginosis. Tinidazole is available in tablets of 250 and 500 mg and the dose varies by indication, being 2 grams as a single oral dose in adults with trichomoniasis and giardiasis, and for 3 to 5 days for moderate or severe forms of amebiasis. Oral tinidazole is generally well tolerated if being used generally for only 1 to 5 days. In most comparison studies, its efficacy and spectrum of activity were found to be similar to those of metronidazole, but it was often better tolerated. Side effects can include metallic or bitter taste, fatigue, dizziness, headache, dyspepsia, nausea, and a disulfiram-like response to alcohol. Rare, but potential serious adverse events include allergic reactions, anaphylaxis and toxic megacolon.

### Hepatotoxicity

Tinidazole is typically given for a few days only, but serum enzyme elevations have been reported with its use, and serum enzyme elevations during therapy is listed as a possible adverse event in the product label. Tinidazole is also capable of causing anaphylactic and allergic reactions including urticaria, angioedema and bronchospasm, reactions which can be associated with minor serum enzyme elevations. Tinidazole, despite considerable use worldwide, has not been linked convincingly to instances of clinically apparent liver injury with jaundice.

Likelihood score: E* (suspected but unproven rare cause of clinically apparent liver injury)

### Mechanism of Injury

The cause of rare instances of serum enzyme elevations with tinidazole therapy is unknown, but is likely to be immunologically mediated. Tinidazole is extensively metabolized in the liver largely via CYP 3A4 and can lead to significant drug-drug interactions.

### Outcome and Management

The severity of the liver injury linked to tinidazole therapy has been invariably mild and self-limited, usually with transient, asymptomatic serum enzyme elevations accompanying hypersensitivity reactions. However, the use of tinidazole has been limited and it is typically given for 1 to 5 days only. In instances of allergic reactions or anaphylaxis, rechallenge should be avoided. There is no information to suggest that there is cross sensitivity to hypersensitivity reactions or hepatic injury between tinidazole and other antimicrobial agents; indeed, some patients have had severe hypersensitivity reactions to tinidazole after tolerating a course of metronidazole.

Drug Class: Antiinfective Agents

Other Drugs in the Subclass, Nitroimidazoles: Benznidazole, Metronidazole, Secnidazole

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Tinidazole – Generic, Tindamax®

DRUG CLASS

Antiinfective Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Tinidazole)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Tinidazole | 19387-91-8 | C8-H13-N3-O4-S

## ANNOTATED BIBLIOGRAPHY

References updated: 20 February 2020

Zimmerman HJ. Amebicides. Hepatic injury from antimicrobial agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, p. 592. (Expert review of liver injury published in 1999 mentions that metronidazole has only rarely been incriminated in causing liver injury).
Moseley RH. Hepatotoxicity of antimicrobials and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 463-82. (Review of hepatotoxicity of antibiotics; does not discuss tinidazole).
Wetzel DM, Phillips MA. Chemotherapy of protozoal infections. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 987-1000. (Textbook of pharmacology and therapeutics).
Rosenthal PJ. Antiprotozoal drugs. In, Katzung BG, Masters SB, Trevor AJ. Basic and clinical pharmacology. 12th ed. New York: McGraw Hill, 2012, pp. 915-36. (Textbook of pharmacology and therapeutics, mentions that tinidazole has similar activity as metronidazole, but better toxicity profile and simpler dosing regimens).
McEwen J. (1983). Hypersensitivity reactions to tinidazole (Fasigyn). Med J Aust. (Report of 10 instances of hypersensitivity reactions to tinidazole from an Australian registry, all arising within 24 hours of the first dose, 9 being severe and including generalized urticaria, facial or laryngeal edema, hypotension, bronchospasm and dyspnea; no mention of ALT elevations or jaundice).
Howard K. (1985). Tinidazole and hepatitis. Med J Aust. (4 year old girl with giardiasis developed peripheral and facial edema within 3 days of a single oral dose of tinidazole [bilirubin 0.5 mg/dL, AST 231 U/L, CK 1498 U/L], resolving within a few days and liver tests being normal two weeks later).
Roe FJ. (1985). Safety of nitroimidazoles. Scand J Infect Dis Suppl. (Review of the safety of tinidazole and other nitroimidazoles mentions side effects of nausea, headaches, metallic taste, furred tongue, itching and skin rash and at least one report of transient serum enzyme elevations).
(2004). Tinidazole (Tindamax) - a new anti-protozoal drug. Med Lett Drugs Ther. (Concise summary of activity, efficacy, side effects and costs of tinidazole shortly after its approval in the US, mentions that side effects were similar to metronidazole; no mention of ALT elevations or hepatotoxicity).
Fung HB, Doan TL. (2005). Tinidazole: a nitroimidazole antiprotozoal agent. Clin Ther. (Thorough review of structure, mechanism of action, pharmacology, efficacy and side effects of tinidazole in protozoal disease and bacterial vaginitis; adverse events were reported in 9-11% of recipients, most commonly metallic taste and nausea; no mention of ALT elevations or hepatotoxicity).
Singbal SS, Rataboli PV. (2005). Anaphylaxis and hypersensitivity syndrome reactions in increasing severity following repeated exposure to tinidazole. J Postgrad Med. (30 year old man developed Stevens Johnson syndrome within a few days of starting tinidazole and norfloxacin, and had recurrence after starting single doses of both and another a third time when he took a half pill of tinidazole alone, having previously tolerated metronidazole; no mention of liver involvement or ALT levels).
Livengood CH, Ferris DG, Wiesenfeld HC, Hillier SL, Soper DE, Nyirjesy P, Marrazzo J, et al. (2007). Effectiveness of two tinidazole regimens in treatment of bacterial vaginosis: a randomized controlled trial. Obstet Gynecol. (Among 235 women with bacterial vaginosis treated with tinidazole [1 g daily for 5 days or 2 g daily for 2 days] or placebo, cure rates were higher with tinidazole [36% and 27%] versus placebo [5%]; side effects included dysgeusia [26% and 40% vs 5%] and nausea and dizziness; tinidazole had "no clinically significant effect" on liver function tests).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US between 2004 and 2008, more than 100 agents were implicated and the most commonly implicated class of agents was antibiotics, but no case was attributed to tinidazole or metronidazole).
Escobedo AA, Alvarez G, González ME, Almirall P, Cañete R, Cimerman S, Ruiz A, et al. (2008). The treatment of giardiasis in children: single-dose tinidazole compared with 3 days of nitazoxanide. Ann Trop Med Parasitol. (Among 166 children with giardiasis who were treated with tinidazole [3 g single dose] or nitazoxanide [twice daily for 3 days], cure rates were 90% vs 78% and there were only mild, transient side effects; no mention of ALT elevations or hepatotoxicity).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to tinidazole or metronidazole).
Drugs for parasitic infections. 2nd ed. New Rochelle, NY: Medical Letter, Inc., 2010. (Thorough description of drugs for parasitic infections in adults and children as well as a table of their major side effects; tinidazole, like metronidazole, is considered a first line agent for treatment of amebiasis, giardiasis and trichomonas infections; side effects are listed as occasional [metallic taste, GI symptoms, rash] and rare [weakness]).
Pasupuleti V, Escobedo AA, Deshpande A, Thota P, Roman Y, Hernandez AV. (2014). Efficacy of 5-nitroimidazoles for the treatment of giardiasis: a systematic review of randomized controlled trials. PLoS Negl Trop Dis. (Systematic review of 30 randomized controlled trials in 3930 patients comparing nitroimidazoles to placebo in giardiasis; mentions that harmful outcomes were uncommon and side effects reported more commonly than with placebo included only metallic taste and headache; no mention of ALT levels or hepatotoxicity).
Blumenthal KG, Youngster I, Rabideau DJ, Parker RA, Manning KS, Walensky RP, Nelson SB. Peripheral blood eosinophilia and hypersensitivity reactions among patients receiving outpatient parenteral antibiotics. J Allergy Clin Immunol 2015; 136: 1288-94. e1. (Among 824 patients receiving outpatient parenteral antibiotic therapy who had concurrent white blood cell and differential counts, eosinophilia [>500 cells/uL] was found in 25%, being most common with vancomycin [30%], the penicillins [28%], carbapenems [28%], cephalosporins [22%], fluoroquinolones [21%], and less common with metronidazole [15%] and there was no association of eosinophilia with liver test abnormalities).
(2017). Drugs for Helicobacter pylori infection. Med Lett Drugs Ther. (Concise review of the efficacy, safety and costs of drugs for H. pylori infection lists preferred regimens, usually include metronidazole [500 mg twice daily for 10-14 days] or tinidazole at the same dosage, whose adverse effects can include metallic taste, reactions to alcohol, seizures and neuropathy).
Pandey S, Gupta GK, Wanjari SJ, Nijhawan S. (2018). Comparative study of tinidazole versus metronidazole in treatment of amebic liver abscess: A randomized control trial. Indian J Gastroenterol. (Among 150 patients with amebic liver abscess treated with metronidazole [14 days] or tinidazole [5 days], time to response was better with tinidazole but ultimate response rates were similar, although metronidazole was associated with a higher rate of adverse events including nausea, vomiting and metallic taste resulting in early discontinuation in 10%; no mention of ALT elevations or hepatotoxicity).
Shamberg L, Vaziri H. (2018). Hepatotoxicity of Inflammatory Bowel Disease Medications. J Clin Gastroenterol. (Review of the hepatotoxicity of drugs used for inflammatory bowel disease mentions that metronidazole has been reported to cause liver injury, but it is rare and does not justify prospective monitoring during therapy).
Ataee P, Karimi A, Eftekhari K. (2020). Hepatic failure following metronidazole in children with Cockayne syndrome. Case Rep Pediatr. (Two cases: 2 and 5 years old boys with type B [infant onset] Cockayne syndrome developed jaundice, vomiting and agitation 2 and 3 days after starting oral metronidazole for minor infection [bilirubin 13.7 and 16.0 mg/dL, ALT 2815 and 2248 U/L, Alk P 1265 and 1654 U/L, INR 5.1 and 4.6], one dying within 2 days of admission and the second recovering but with persistent jaundice and serum enzyme elevations one month later; whether similar reactions occur with tinidazole is uncertain).

## OTHER REFERENCE LINKS

1 Recent References on Tinidazole: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Tinidazole/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Tinidazole: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Tinidazole)